# Interferon Gamma

## OVERVIEW

### Introduction

Interferon gamma is a recombinant cytokine with a multitude of actions including stimulation of T cell immunity, increase in innate immune responses, induction of Class II major histocompatibility complex molecules, and inhibition of fibrosis. Interferon gamma is used for its immune enhancing properties as therapy of chronic granulomatous disease of childhood and is used experimentally for its anti-fibrotic actions. Therapy with interferon gamma can cause mild elevations in serum enzymes, but has not been linked to cases of clinically significant liver injury.

### Background

Interferon gamma (in' ter feer" on) is human cytokine produced by macrophages and lymphocytes that plays a critical role in both innate and adaptive immune responses. While also known as type II interferon, interferon gamma has only modest direct antiviral activity and is unrelated in structure, genetic linkage and function to the type I interferons, such as interferon alpha, beta and lambda. It more closely resembles an interleukin and activates macrophages and increases Class II major histocompatibility complex (MHC) expression on cells. Absence of interferon gamma or its receptor is associated with autoinflammatory conditions and autoimmune diseases. Interferon gamma has been evaluated as a therapy of multiple conditions, as an antiviral agent for hepatitis B and C, as an antifibrotic agent in chronic liver disease and pulmonary fibrosis, and as an immunomodulatory agent in several immune deficiency syndromes including AIDS and chronic granulomatous disease (CGD) of childhood. Interferon gamma-1b was approved for use in the United States for CGD in 1990 and remains an experimental agent for other uses. Interferon gamma-1b is available as a solution in single use vials of 100 µg (2 million IU) in 0.5 mL under the brand name Actimmune. The typical adult dose is 50 µg/m^2^ (body surface area >0.5 m^2^) and 1.5 µg/kg/dose in small children (body surface area ≤0.5 m^2^) subcutaneously three times weekly. Side effects are common with the initial dose and include fever, malaise, body aches and nausea. With chronic therapy, injection site reactions, fatigue, headache and muscle aches are common. Rare, but potentially severe adverse reactions include hypersensitivity reactions.

### Hepatotoxicity

In multiple phase 2 and 3 clinical trials, interferon gamma was found to cause mild-to-moderate serum enzyme elevations in in small portion of patients. The elevations were generally transient and without jaundice or obvious symptoms of liver injury, but rose to levels above 5 to 10 times ULN and necessitated dose modification or discontinuation in a proportion of patients, particularly in children less than one year of age. Nevertheless, no instances of clinically apparent acute liver injury with jaundice attributable to interferon gamma therapy have been reported, although the product label mentions "hepatitis" as a potential complication of therapy. Thus, interleukin-2 has been clearly linked to serum enzyme elevations during treatment, but has not been implicated in cases of idiosyncratic, acute liver injury with jaundice.

Likelihood score: E (Unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which interferon gamma infusions might cause liver injury is unclear as it is a recombinant human protein and thus is unlikely to have direct hepatotoxicity. The induction of activated T cells, however, may be associated with some degree of hepatic inflammation and injury, but is not likely to cause frank acute liver damage. Interleukin-2 also has multiple other actions that may account for its many side effects, including activation of natural killer cells, increases in other cytokines (tumor necrosis factor alpha, interferon gamma) and stimulation of eosinophils. Interleukin-2 has been implicated in causing vasculitis in other organs and chronic vasculitis in the liver may have consequences on liver function and injury.

### Outcome and Management

The serum enzyme elevations during interferon gamma therapy are generally self-limited and benign. However, such elevations are more frequent and more marked in children less than one year of age, in whom monthly monitoring of liver tests is recommended. In situations in which ALT or AST levels rise above 5 times ULN, dose modification or temporary discontinuation is prudent.

Other cytokines used in medicine include interferon alfa and beta, interleukin-2 and the hematologic growth factors such as erythropoietin, colony stimulating factors and interleukin 11.

Drug Class: Antineoplastic Agents, Cytokines, Biologic Response Modifiers

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Interferon gamma – Actimmune®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Aldesleukin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Interferon gamma-1b | 98059-61-1 | Cytokine | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 03 May 2018

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of recombinant interferon gamma).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of drug induced liver injury published in 2013; interferon gamma is not discussed).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, Longo DL, Mitsiades C, Richardson P. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
Sechler JM, Malech HL, White CJ, Gallin JI. Recombinant human interferon-gamma reconstitutes defective phagocyte function in patients with chronic granulomatous disease of childhood. Proc Natl Acad Sci U S A 1988; 85: 4874-8. (Three patients with CGD treated with interferon gamma [10 µg per meter squared subcutaneously daily for 5 days] demonstrated improvements in bactericidal activity of monocytes and neutrophils, but "had no changes in blood chemistry"). 2838849
A controlled trial of interferon gamma to prevent infection in chronic granulomatous disease. The International Chronic Granulomatous Disease Cooperative Study Group. N Engl J Med 1991; 324: 509-16. (Among 129 patients with CGD treated with interferon gamma [50 µg per square meter] or placebo subcutaneously 3 times weekly for up to a year, those receiving interferon had fewer serious infections; side effects of interferon gamma included fever, headache, and chills with initial injections but led to no serious adverse events or changes in "biochemical indexes"). 1846940
Gleave ME, Elhilali M, Fradet Y, Davis I, Venner P, Saad F, Klotz LH, et al. Interferon gamma-1b compared with placebo in metastatic renal-cell carcinoma. Canadian Urologic Oncology Group. N Engl J Med 1998; 338: 1265-71. (Among 181 patients with metastatic renal cell cancer treated with interferon gamma or placebo, overall response and survival rates were similar in the two groups as were serious adverse event rates; no mention of ALT elevations or hepatotoxicity). 9562580
Wasserman D, Ioannovich JD, Hinzmann RD, Deichsel G, Steinmann GG. Interferon-gamma in the prevention of severe burn-related infections: a European phase III multicenter trial. The Severe Burns Study Group. Crit Care Med 1998; 23: 434-9. (Among 216 patients with severe burns treated with interferon gamma or placebo for up to 90 days, infection, mortality and serious adverse event rates were similar in the two groups; no mention of ALT elevations or hepatotoxicity). 9504568
Ziesche R, Hofbauer E, Wittmann K, Petkov V, Block LH. A preliminary study of long-term treatment with interferon gamma-1b and low-dose prednisolone in patients with idiopathic pulmonary fibrosis. N Engl J Med 1999; 341: 1264-9. (Among 18 patients with idiopathic pulmonary fibrosis [IPF] treated with prednisolone with or without interferon gamma for one year, pulmonary function and resting oxygen saturation improved more in interferon gamma treated subjects). 10528036
Raghu G, Brown KK, Bradford WZ, Starko K, Noble PW, Schwartz DA, King TE Jr; Idiopathic Pulmonary Fibrosis Study Group. A placebo-controlled trial of interferon gamma-1b in patients with idiopathic pulmonary fibrosis. N Engl J Med 2004; 350: 125-33. (Among 330 patients with idiopathic pulmonary fibrosis not responding to corticosteroids treated with interferon gamma or placebo for an average of 58 weeks, there were no differences in rates of pulmonary worsening or progression-free survival; and, while fever, influenza-like symptoms and nausea were more frequent with interferon, ALT elevations and hepatotoxicity were not mentioned). 14711911
Soza A, Heller T, Ghany M, Lutchman G, Jake Liang T, Germain J, Hsu HH, Park Y, Hoofnagle JH. Pilot study of interferon gamma for chronic hepatitis C. J Hepatol 2005; 43: 67-71. (Among 14 patients with chronic hepatitis C not responding to interferon alfa and ribavirin, a 4 week course of interferon gamma [100, 200 or 400 µg three times weekly] had no effects on HCV RNA or ALT levels and side effects included influenza-like symptoms after the first injection). 15913831
Muir AJ, Sylvestre PB, Rockey DC. Interferon gamma-1b for the treatment of fibrosis in chronic hepatitis C infection. J Viral Hepat 2006; 13: 322-8. (Among 20 patients with chronic hepatitis C treated with interferon gamma [200 µg thrice weekly] for 24 weeks, liver fibrosis and histologic activity scores did not change; one patient had a 2 fold increase in serum ALT levels on therapy that resolved upon stopping, but no further details were given). 16637863
Antoniou KM, Nicholson AG, Dimadi M, Malagari K, Latsi P, Rapti A, Tzanakis N, et al. Long-term clinical effects of interferon gamma-1b and colchicine in idiopathic pulmonary fibrosis. Eur Respir J 2006; 28: 496-504. (Among 50 patients with idiopathic pulmonary fibrosis treated with interferon gamma or colchicine for 2 years, side effects included fever, myalgia, and influenza-like symptoms, but serum ALT levels and hepatotoxicity were not mentioned). 16611657
King TE Jr, Albera C, Bradford WZ, Costabel U, Hormel P, Lancaster L, Noble PW, et al.; INSPIRE Study Group. Effect of interferon gamma-1b on survival in patients with idiopathic pulmonary fibrosis (INSPIRE): a multicentre, randomised, placebo-controlled trial. Lancet 2009; 374 (9685): 222-8. (Among 826 patients with idiopathic pulmonary fibrosis treated with interferon gamma [200 µg thrice weekly] or placebo daily for an average of 1.5 years, survival rates and worsening of pulmonary function were similar in the two groups; no mention of ALT elevations or hepatotoxicity). 19570573
Richeldi L. Assessing the treatment effect from multiple trials in idiopathic pulmonary fibrosis. Eur Respir Rev 2012; 21: 147-51. (Review of trials of agents in idiopathic pulmonary fibrosis; mentions two trials of interferon gamma, neither of which showed a clinical benefit [Raghu 2004, King 2009]; no mention of adverse events). 22654087
Seyer L, Greeley N, Foerster D, Strawser C, Gelbard S, Dong Y, Schadt K, et al. Open-label pilot study of interferon gamma-1b in Friedreich ataxia. Acta Neurol Scand 2015; 132: 7-15. (Among 12 children and adolescents with Friedreich ataxia treated with interferon gamma for 12 weeks, adverse events were frequent but usually mild, 2 patients required dose reduction and "liver function abnormalities" arose in 1 subject, no details given). 25335475

## OTHER REFERENCE LINKS

1. Recent References on Interferon Gamma: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Interferon+Gamma/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Interferon Gamma: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Interferon+Gamma)